# Leflunomide

## OVERVIEW

### Introduction

Leflunomide is an immunomodulatory agent used in the therapy of rheumatoid arthritis and psoriatic arthritis. Leflunomide therapy is associated with frequent elevations in serum aminotransferase levels and with rare instances of clinically apparent acute liver injury which can be severe and even fatal.

### Background

Leflunomide (le floo' noe mide) is an isoxazole derivative that is rapidly converted to its active metabolite teriflunomide (ter" i floo' noe mide) in the gut wall and liver. Leflunomide acts by inhibition of dihydroorotate dehydrogenase, which is a rate limiting step in pyrimidine synthesis necessary for DNA replication of rapidly dividing cells. Activated T lymphocytes are particularly sensitive to the inhibition of pyrimidine synthesis caused by leflunomide. Leflunomide is effective in reducing pain, improving functional status and decreasing the rate of injury in rheumatoid and psoriatic arthritis and is considered a “disease modifying antirheumatic agent (DMARD).” Leflunomide was approved for use in the United States in 1998 and is currently in wide use. Leflunomide is available in tablets of 10, 20 and 100 mg generically and under the brand name of Arava. The usual recommended dose is 100 mg daily for three days followed by 20 mg daily, reducing the dose of 10 mg daily if tolerance is poor. Common side effects include fever, rash, headache, infections, alopecia, gastrointestinal upset, nausea, and diarrhea. Rare but potentially severe adverse events include hypertension, peripheral neuropathy, interstitial lung disease, severe infections, hepatotoxicity, hypersensitivity reactions, Stevens-Johnson syndrome (SJS), Toxic epidermal necrosis (TEN), and embryo-fetal toxicity.

### Hepatotoxicity

Up to 15% of subjects treated with leflunomide develop transient serum aminotransferase elevations that are usually asymptomatic and mild, in the range of 1 to 3 times the upper limit of normal (ULN). Elevations above 3 times the ULN occur in 1% to 4% of patients.

In addition, leflunomide is associated with rare instances of clinically apparent liver injury that can be severe. The liver injury usually arises after 1 to 6 months of therapy (often associated with diarrhea) and presents with a range of patterns of enzyme elevations from cholestatic to hepatocellular. Rash and fever can occur, but are usually not prominent. Autoimmune features are often present, but are usually related to the underlying rheumatic condition rather than leflunomide therapy or liver injury. The injury begins to resolve within a week of stopping therapy, although several cases of acute liver failure resulting in death or need for urgent liver transplantation have been described. The current product labels for leflunomide have a boxed warning regarding hepatotoxicity. The estimated incidence of clinically apparent liver injury from leflunomide is probably 1:1,000 to 1:,5000 exposed persons.

Interestingly, cases of leflunomide induced liver injury reported from India differ from that described in Western countries in clinical features and outcome. Indian patients with leflunomide liver injury typically present after 1-2 months rash and fever and often with severe cutaneous reactions such as Drug Reaction with Eosinophilia and Systemic Symptoms (DRESS syndrome) or Stevens-Johnson syndrome (SJS) or Toxic Epidermal Necrolysis (TEN). Most cases have been described in women, and the morbidity and mortality rates are high. The reasons for these differences is not known but are likely genetic.

Finally, leflunomide has been associated with reactivation of hepatitis B in patients with rheumatoid arthritis who are also HBsAg positive. Without prophylaxis (using an oral antiviral agent with activity against HBV), the frequency of reactivation is at least 50% in HBsAg positive individuals. Severe hepatitis and deaths have been described.

Likelihood score: B (well known cause of idiosyncratic clinically apparent liver injury as well as reactivation of hepatitis B).

### Mechanism of Injury

The hepatic injury due to leflunomide is thought to be due to production of a toxic or immunogenic intermediate. Leflunomide is extensively metabolized by the liver and is a potent inhibitor of CYP 2C9. Hepatotoxicity of leflunomide has been linked to the cytochromic allelic variants CYP 2C9*2 and *3, both of which are associated with impaired metabolism of the substrate. The mechanism of injury from HBV reactivation is believed to be due to immunosuppression which causes increases in HBV replication and subsequent immune reaction to the increase in viral antigens.

### Outcome and Management

The mild ALT elevations associated with leflunomide therapy are usually asymptomatic, self limited and rarely require dose modification or discontinuation. Nevertheless, monitoring of serum enzymes is recommended, before starting therapy, monthly for the first 6 months, and then every other month. In instances in which ALT levels rise above 3 times ULN, repeat testing and dose modification is recommended as well as discontinuation if levels remain above this cut off. The acute liver injury due to leflunomide is usually self limited once therapy is stopped, but severe and fatal cases have been reported. Because of the enterohepatic circulation and long half life of leflunomide, therapy with a bile acid resin such as cholestyramine (4 grams every 6 hours for 2 weeks) is recommended to speed clearance of the drug. Patients with clinically apparent liver disease due to leflunomide should not be reexposed to the drug. There does not appear to be cross reactivity in regard to hepatic injury with other disease modifying rheumatologic agents such as azathioprine, thioguanine, mycophenolate, cyclosporine, or tacrolimus. Teriflunomide, the active metabolic product of leflunomide, is now a FDA approved drug as therapy for multiple sclerosis, but not for inflammatory forms of arthritis. It is likely that there is a shared sensitivity to liver injury between the two “flunomides”.

Patients who are scheduled to start leflunomide therapy should be screened for hepatitis B status: HBsAg and anti-HBc and possibly anti-HBs. Patients with HBsAg in serum should be provided with antiviral prophylaxis preferably with a potent nucleoside analogue with a high barrier to resistance such as tenofovir or entecavir for the duration of therapy. Patients with anti-HBc without HBsAg in serum may be offered prophylaxis but may also be monitored for HBV replication status (HBV DNA) and perhaps offered HBV immunization to boost titers of anti-HBs. Patients who have rises in HBV DNA levels during leflunomide therapy should be started on antiviral therapy.

Drug Class: Antirheumatic Agents

## CASE REPORTS

### Case 1. Acute hepatitis due to leflunomide(1).

A 67 year old woman with rheumatoid arthritis with an inadequate response to methotrexate (12.5 mg weekly for 2 years) was switched to leflunomide 20 mg daily and aurothiomalate weekly. Fifteen days later she developed diarrhea and leflunomide was stopped. Two weeks later she still had diarrhea and noted the onset of jaundice. On examination, she was icteric but had no fever, rash or other signs of acute or chronic liver disease. Laboratory results showed a total serum bilirubin level of 2.8 mg/dL and elevations in both serum aminotransferase and alkaline phosphatase levels (Table). She was known to have had normal liver tests in the past during regular monitoring of methotrexate therapy. ANA levels were weakly positive (1:80), but tests for hepatitis A, B and C were negative. A liver biopsy showed mild inflammation and acute liver injury without fibrosis or steatosis. Genetic testing showed that she was homologous for CYP 2C9*3. She was treated with cholestyramine and improved. Three months later serum enzyme levels were normal.

#### Key Points

Medication: | Leflunomide (20 mg daily) for 15 days
Pattern: | Hepatocellular (R=5.1)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 2 weeks to diarrhea, 4 weeks to jaundice
Recovery: | 1-2 months
Other medications: | Aurothiomalate; ongoing long term therapy with enalapril, prednisone, omeprazole, alendronate, calcium and vitamin D; previous therapy with methotrexate

#### Laboratory Values

Time After Starting | Weeks After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
4 weeks | 2 weeks | 462 | 602 | 2.8 | ESR 19 mm/hr
| 2.5 weeks | 550 | 777 | 3.5 | Liver biopsy
5 weeks | 3 weeks | 517 | 765 | 2.7
6 weeks | 4 weeks | 270 | 673 | 1.4
8 weeks | 6 weeks | 26 | 390
| | 14 | 175 | 0.6
Normal Values | | <40 | <265 | <1.2

#### Comment

A mild acute hepatitis occurred within a month of starting leflunomide in a patient with a genetic predisposition to toxicity (CYP 2C9*3 homozygosity). The injury may have been more severe had leflunomide not been stopped two weeks before onset of jaundice because of diarrhea. The injury was weakly hepatocellular in pattern and more similar to a mixed hepatocellular-cholestatic pattern. The liver biopsy showed a pattern of acute liver injury without evidence of methotrexate hepatotoxicity or underlying liver disease. The concurrent use of aurothiomalate, a gold salt which is also associated with cholestatic liver injury, makes it difficult to definitely attribute the hepatic injury to leflunomide. However, the timing and pattern of onset was not typical for gold induced hepatotoxicity (which typically is associated with fever, rash and eosinophilia). A large proportion of cases of suspected leflunomide induced liver injury in the literature occurred in the context of exposure to other potentially hepatotoxic medications (itraconazole, methotrexate, nonsteroidal antiinflammatory agents). Nevertheless, routine monthly monitoring of serum aminotransferase levels is recommended during the initial six months of leflunomide therapy.

### Case 2. Cholestatic hepatitis due to leflunomide(2).

An 84 year old man with polymyalgia rheumatic and incomplete responses to courses of prednisone and methotrexate was placed on leflunomide 20 mg daily. Ten weeks later, his arthritis had improved and leflunomide was stopped and replaced by hydroxychloroquine 200 mg twice daily. Four weeks later he noted darkening of the urine and jaundice and was hospitalized. He denied nausea, vomiting, poor appetite, abdominal pain or itching. He had no history of liver disease and serum enzymes had been normal on many occasions (Table). He did not drink alcohol and had no risk factors for viral hepatitis. On examination, he was jaundiced but without rash, fever or signs of chronic liver disease. Laboratory tests showed a total serum bilirubin of 9.8 mg/dL, with marked elevations in alkaline phosphatase (632 U/L) and modest elevations in ALT (121 U/L) and AST (122 U/L). Serum albumin was borderline low (3.6 g/dL), but the INR was normal (1.2). Tests for hepatitis A, B and C, antinuclear antibody and smooth muscle antibody were negative. CT scan of the abdomen showed no evidence of bile or pancreatic duct dilation and no gallstones. The liver was echogenic, suggestive of fatty infiltration. Hydroxychloroquine was stopped upon admission, but he remained jaundiced. An MRI of the abdomen and subsequent ERCP showed normal pancreatic and extrahepatic bile ducts without evidence of stones or obstruction. He was discharged and followed regularly. Two months later he was no longer jaundiced, but serum ALT and alkaline phosphatase levels remained mildly elevated for more than six months. Because of persistent arthralgias, he was restarted on hydroxychloroquine and had no recurrence of jaundice or serum enzyme elevations.

#### Key Points

Medication: | Leflunomide (20 mg daily) for 12 weeks
Pattern: | Cholestatic (R=0.6)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 16 weeks (4 weeks after stopping)
Recovery: | 3-6 months
Other medications: | Hydroxychloroquine, multivitamins

#### Laboratory Values

Weeks After Starting | Weeks After Stopping | ALT (U/L)
0 | | Leflunomide (20 mg daily) started
8 | 0 | 30 | 95 | 0.6
12 | 0 | Leflunomide stopped, hydroxychloroquine started
16 | 4 | 121 | 632 | 9.8 | CT Scan
17 | 5 | 98 | 500 | 9.3
18 | 6 | 106 | 575 | 6.5 | ERCP
21 | 9 | 86 | 704 | 3.3
26 | 14 | 67 | 545 | 1.4
30 | 18 | 65 | 520 | 1.0
32 | 20 | 52 | 414 | 0.8
40 | 28 | 45 | 185 | 0.6
48 | 36 | 66 | 291 | 0.5
52 | 40 | 41 | 263 | 0.3
58 | 48 | 35 | 170 | 0.4
58 | | Hydroxychloroquine restarted
62 | | 24 | 110 | 0.4
86 | | 29 | 103 | 0.5
Normal Values | | <40 | <115 | <1.2

#### Comment

The initial consideration was malignant obstruction of the biliary tract, but repeated imaging and ERCP failed to show evidence of extrahepatic obstruction. Drug induced liver injury appeared to be the most likely diagnosis, but it was unclear whether the injury was caused by leflunomide or hydroxychloroquine. The delay in onset after stopping leflunomide was unusual, but the agent has a very prolonged half life and undergoes entero-hepatic recirculation. Clinical recovery was complete within a few months of onset, but the patient had persistent abnormalities of serum ALT and alkaline phosphatase that did not fall into the normal range until 9 months after initial presentation. Slow recovery is not unusual in cholestatic forms of drug induced liver disease. Hydroxychloroquine, which has rarely been implicated in drug induced liver injury, was restarted and serum enzyme and bilirubin levels remained normal.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Leflunomide – Generic, Arava®

DRUG CLASS

Antirheumatic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Leflunomide)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Leflunomide | 75706-12-6 | C12-H9-F3-N2-O2 | SID:

## CITED REFERENCES

1 Sevilla-Mantilla C, Ortega L, Agúndez JA, Fernández-Gutiérrez B, Ladero JM, Díaz-Rubio M. Leflunomide-induced acute hepatitis. Dig Liver Dis 2004; 36: 82-4. ]14971821
2 Devarbhavi H, Ghabril M, Barnhart H, Patil M, Raj S, Gu J, Chalasani N, et al. Leflunomide-induced liver injury: differences in characteristics and outcomes in Indian and US registries. Liver Int. 2022;42:1323-1329..35129282

## ANNOTATED BIBLIOGRAPHY

References updated: 10 February 2026

Abbreviations used: ULN, upper limit of normal; DRESS, drug reaction with eosinophilia and systemic symptoms; SJS, Stevens-Johnson syndrome; TEN, toxic epidermal necrolysis.

Zimmerman HJ. Drugs used to treat rheumatic and musculospastic disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 517-54. (Expert review of hepatotoxicity published in 1999 before general availability of leflunomide).
Reuben A. Hepatotoxicity of immunosuppressive drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 569-91. (Review of hepatotoxicity of immunosuppressive agents; in registration trials of leflunomide, ALT elevations were found in 2-19% of treated patients, but no instance of clinically apparent liver injury was found, whereas after approval several reports of severe liver injury from leflunomide appeared).
Krensky AM, Azzi JR, Hafler DA. Immunosuppressants and tolerogens. In, Brunton LL, Hilal-Dandan R, Knollman, BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 637-54. (Textbook of pharmacology and therapeutics).
Smolen JS, Kalden JR, Scott DL, Rozman B, Kvien TK, Larsen A, Loew-Friedrich I, et al. Efficacy and safety of leflunomide compared with placebo and sulphasalazine in active rheumatoid arthritis: a double-blind, randomised, multicentre trial. European Leflunomide Study Group. Lancet 1999; 353: 259-66. (Among 358 patients with rheumatoid arthritis in a placebo controlled trial, 3 of 133 [2%] on leflunomide but none on placebo developed ALT levels above 3 times ULN, and one patient was reported as having "hepatitis"). 9929017
Strand V, Cohen S, Schiff M, Weaver A, Fleischmann R, Cannon G, Fox R, et al. Treatment of active rheumatoid arthritis with leflunomide compared with placebo and methotrexate. Leflunomide Rheumatoid Arthritis Investigators Group. Arch Intern Med 1999; 159: 2542-50. (Among 482 patients with rheumatoid arthritis in a multicenter controlled trial, 4.4% of 182 patients on leflunomide vs 2.5% on placebo developed ALT elevations greater than 3 times ULN [11% vs 3.4% greater than 2 times ULN], all resolved, half despite continuation; no mention of symptoms or jaundice). 10573044
Smolen JS, Graninger WB, Emery P. Leflunomide, a new disease-modifying anti-rheumatic drug and the never ending rheumatoid arthritis story. Rheumatology (Oxford) 2000; 39: 689-92. (Summary of results from 3 large phase III trials of leflunomide vs placebo in 1839 patients; ALT or AST elevations occurred in 5.4% to 14.8%; no mention of jaundice or symptoms). 10908683
Emery P, Breedveld FC, Lemmel EM, Kaltwasser JP, Dawes PT, Gömör B, Van Den Bosch F, et al. A comparison of the efficacy and safety of leflunomide and methotrexate for the treatment of rheumatoid arthritis. Rheumatology (Oxford) 2000; 39: 655-65. (Among 999 patients in a randomized controlled trial for 52 weeks, ALT or AST elevations above 3 times ULN occurred in 5.4% of leflunomide vs 16.3% of methotrexate recipients, causing withdrawal in 1.6% vs 5% of patients). 10888712
Scott DL, Smolen JS, Kalden JR, van de Putte LB, Larsen A, Kvien TK, Schattenkirchner M, et al.; European Leflunomide Study Group. Treatment of active rheumatoid arthritis with leflunomide: two year follow up of a double blind, placebo controlled trial versus sulfasalazine. Ann Rheum Dis 2001; 60: 913-23. (Among patients treated with leflunomide for 12 to 24 months, transient ALT elevations occurred in 3 of 80 [4%] patients; no hypersensitivity or jaundice or liver related deaths). 11557646
Cohen S, Cannon GW, Schiff M, Weaver A, Fox R, Olsen N, Furst D, et al. Two-year, blinded, randomized, controlled trial of treatment of active rheumatoid arthritis with leflunomide compared with methotrexate. Utilization of Leflunomide in the Treatment of Rheumatoid Arthritis Trial Investigator Group. Arthritis Rheum 2001; 44: 1984-92. (Among 190 subjects treated with leflunomide for up to 2 years, 24 [11%] had ALT elevation above 2 times ULN but all resolved, half without change in dose). 11592358
Rozman B. Clinical pharmacokinetics of leflunomide. Clin Pharmacokinet 2002; 41: 421-30. (Leflunomide is almost completely metabolized to its active moiety A77 1726 in the gut wall and liver, the latter having a long elimination half-life which can be shorted by cholestyramine therapy which interrupts its enterohepatic circulation). 12074690
Legras A, Bergemer-Fouquet AM, Jonville-Bera AP. Fatal hepatitis with leflunomide and itraconazole. Am J Med 2002; 113: 352-3. (68 year old with rheumatoid arthritis developed abdominal pain 6 months after starting leflunomide and 2 months after starting itraconazole [ALT 1111 U/L, Alk P 62 U/L], with subsequent worsening, acute liver failure and death, a pattern also compatible with itraconazole related hepatotoxicity). 12361833
Li EK, Tam LS, Tomlinson B. Leflunomide in the treatment of rheumatoid arthritis. Clin Ther 2004; 26: 447-59. (Review of published literature on pharmacology, mechanisms of action, clinical efficacy and safety of leflunomide; ALT elevations occur in 15% of patients, but levels above 3 times ULN in only 2% to 3%). 15189743
Poór G, Strand V; Leflunomide Multinational Study Group. Efficacy and safety of leflunomide 10 mg versus 20 mg once daily in patients with active rheumatoid arthritis: multinational double-blind, randomized trial. Rheumatology (Oxford) 2004; 43: 744-9. (Trial of 10 vs 20 mg of leflunomide daily for 24 weeks in patients with rheumatoid arthritis; ALT elevations occurred in 11% vs 13.5% and were above 3 times ULN in 2% of both dose groups). 15026583
Sevilla-Mantilla C, Ortega L, Agúndez JA, Fernández-Gutiérrez B, Ladero JM, Díaz-Rubio M. Leflunomide-induced acute hepatitis. Dig Liver Dis 2004; 36: 82-4. (67 year old with rheumatoid arthritis developed diarrhea 15 days after starting leflunomide and found to have rising ALT levels thereafter [peak bilirubin 2.8 mg/dL, ALT 462 U/L, Alk P 2.5 times ULN], values falling to normal within 2.5 months of stopping: Case 1). 14971821
van Roon EN, Jansen TL, Houtman NM, Spoelstra P, Brouwers JR. Leflunomide for the treatment of rheumatoid arthritis in clinical practice: incidence and severity of hepatotoxicity. Drug Saf 2004; 27: 345-52. (Among 101 patients with rheumatoid arthritis treated with leflunomide for an average of 10 months, 4% had ALT elevations above 2.5 times ULN, but none had symptoms). 15061688
Suissa S, Ernst P, Hudson M, Bitton A, Kezouh A. Newer disease-modifying antirheumatic drugs and the risk of serious hepatic adverse events in patients with rheumatoid arthritis. Am J Med 2004; 117: 87-92. (Case control analysis of hepatic events in two US health plan cohorts of 41,885 patients with rheumatoid arthritis treated with disease modifying agents, found no increase in cases of serious or nonserious events with leflunomide [rate ratio 0.9] compared to methotrexate, but higher rates with etanercept and infliximab [rate ratio 5.3]). 15234643
Nash P, Thaçi D, Behrens F, Falk F, Kaltwasser JP. Leflunomide improves psoriasis in patients with psoriatic arthritis: an in-depth analysis of data from the TOPAS study. Dermatology 2006; 212: 238-49. (Among 188 patients with psoriasis treated for 24 weeks, ALT elevations above 2 times ULN occurred in 10% of leflunomide [n=96] vs 2% of placebo [n=92] recipients; no jaundice and all resolved although 4 were withdrawn for this reason). 16549920
Antony T, Jose VM, Paul BJ, Thomas T. Efficacy and safety of leflunomide alone and in combination with methotrexate in the treatment of refractory rheumatoid arthritis. Indian J Med Sci 2006; 60: 318-26. (Among 11 patients treated with both leflunomide and methotrexate, one [9%] had ALT elevations above 3 times ULN). 16864918
Chávez-López MA, Ramírez-González A, Martínez-Guevara MA. Acute hepatitis associated to leflunomide in a patient with rheumatoid arthritis. Gastroenterol Hepatol 2007; 30: 430. (48 year old with rheumatoid arthritis developed fever and jaundice 5 weeks after starting leflunomide [with etoricoxib and hydroxychloroquine], with ALT 644 U/L, bilirubin not provided; resolving in 8 weeks). 17692207
Karakayali H, Ekici Y, Ozcay F, Bilezikci B, Arslan G, Haberal M. Pediatric liver transplantation for acute liver failure. Transplant Proc 2007; 39: 1157-60. (Among 12 children undergoing liver transplant for acute liver failure at a single center in Turkey, 1 case was attributed to combination of hepatitis B and leflunomide liver injury; no details provided). 17524919
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, leflunomide was considered the cause in one case: Case 2). 18955056
Toscano E, Cotta J, Robles M, Lucena MA, Andrade RJ. [Hepatotoxicity induced by new immunosuppressants]. Gastroenterol Hepatol 2009; 33: 54-65. Spanish. PMID: 19889479 (Extensive review of hepatotoxicity of rheumatologic agents including leflunomide; recommends ALT or AST monitoring for first 6 months of therapy).
Curtis JR, Beukelman T, Onofrei A, Cassell S, Greenberg JD, Kavanaugh A, Reed G, et al. Elevated liver enzyme tests among patients with rheumatoid arthritis or psoriatic arthritis treated with methotrexate and/or leflunomide. Ann Rheum Dis 2010; 69: 43-7. (In a large, observational US database, ALT or AST elevations were found in 17% of patients on leflunomide alone, 22% on methotrexate alone and 31% on both; levels above 2 times ULN in only 2% vs 1% vs 5% [on both]; risk factors for elevations were methotrexate dose, history of liver disease and alcohol use [1-2 drinks/day]). 19147616
Alcorn N, Saunders S, Madhok R. Benefit-risk assessment of leflunomide: an appraisal of leflunomide in rheumatoid arthritis 10 years after licensing. Drug Saf. 2009; 32: 1123-34. (Systematic review of literature on leflunomide in rheumatoid arthritis; 4 randomized controlled trials found leflunomide superior in efficacy to placebo and similar to methotrexate and sulfasalazine; high rates of discontinuation; ALT elevations more than twice ULN in 2% to 19% of patients, usually minor and transient; routine monthly monitoring for first 6 months is now recommended). 19916579
Sokolove J, Strand V, Greenberg JD, Curtis JR, Kavanaugh A, Kremer JM, Anofrei A, et al.; CORRONA Investigators. Risk of elevated liver enzymes associated with TNF inhibitor utilisation in patients with rheumatoid arthritis. Ann Rheum Dis 2010; 69: 1612-7. (Retrospective analysis of ALT and AST elevations among 6861 patients with rheumatoid arthritis enrolled in a North American database receiving tumor necrosis factor [TNF] inhibitors, followed for an average of 1.5 years with ~1.7 determinations yearly; any elevation of ALT or AST occurred in 5.4% of visits, above 2 times ULN in 0.6%, and above 5 times ULN in 0.1%; rates slightly higher for those on infliximab or methotrexate and leflunomide). 20448284
Devarbhavi H, Dierkhising R, Kremers WK, Sandeep MS, Karanth D, Adarsh CK. Single-center experience with drug-induced liver injury from India: causes, outcome, prognosis, and predictors of mortality. Am J Gastroenterol 2010; 105: 2396-404. (Among 313 patients with drug induced liver injury seen between 1997 and 2008 in a single Indian medical center, 4 [1%] were attributed to leflunomide, 3 of which were fatal). 20648003
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 [11%] were attributed to drug induced liver injury, but none were linked to leflunomide). 20949552
Gupta R, Bhatia J, Gupta SK. Risk of hepatotoxicity with add-on leflunomide in rheumatoid arthritis patients. Arzneimittelforschung 2011; 61: 312-6. (Among 46 patients with rheumatoid arthritis in whom leflunomide was added to another disease modifying agents, 10 [22%] developed ALT or AST elevations, but levels were above 3 times ULN in only 1 patient and none developed clinically apparent liver injury). 21755815
Alves JA, Fialho SC, Morato EF, Castro GR, Zimmermann AF, Ribeiro GG, Neves FS, et al. Liver toxicity is rare in rheumatoid arthritis patients using combination therapy with leflunomide and methotrexate. Rev Bras Reumatol 2011; 51: 141-4. (Among 71 patients with rheumatoid arthritis followed at a single referral hospital in Brazil, abnormal liver tests were detected in 11.5% of methotrexate and 11.1% on the combination of leflunomide and methotrexate). 21584420
Vaish AK, Tripathi AK, Gupta LK, Jain N, Agarwal A, Verma SK. An unusual case of DRESS syndrome due to leflunomide. BMJ Case Rep 2011; 2011. PMID: 22679188 (40 year old Indian man developed fever and rash with oral involvement followed by jaundice 20 days after starting leflunomide [bilirubin 9.0 mg/dL, ALT 1350 U/L, Alk P 399 U/L, eosinophils 28%], resolving rapidly with prednisone therapy).
Anelli MG, Scioscia C, Grattagliano I, Lapadula G. Old and new antirheumatic drugs and the risk of hepatotoxicity. Ther Drug Monit 2012; 34: 622-8. (Review of the hepatotoxicity of the major antirheumatic drugs focusing upon anti-TNF agents). 23128910
Jaimes-Hernández J, Meléndez-Mercado CI, Mendoza-Fuentes A, Aranda-Pereira P, Castañeda-Hernández G. Efficacy of leflunomide 100mg weekly compared to low dose methotrexate in patients with active rheumatoid arthritis. Double blind, randomized clinical trial. Reumatol Clin 2012; 8: 243-9. (Among 85 patients with rheumatoid arthritis treated with once weekly leflunomide or methotrexate, ALT elevations above 2.5 times ULN occurred in 9% on leflunomide and 5% of methotrexate; no instance of clinically apparent liver injury). 22763150
Lee SW, Park HJ, Kim BK, Han KH, Lee SK, Kim SU, Park YB. Leflunomide increases the risk of silent liver fibrosis in patients with rheumatoid arthritis receiving methotrexate. Arthritis Res Ther 2012; 14: R232. (Among 105 patients with rheumatoid arthritis on methotrexate, ultrasound elastography revealed increased hepatic stiffness suggestive of fibrosis in 24 [23%]; factors associated with increased values were cumulative dose of prednisone and leflunomide, but not methotrexate). 23107811
Bird P, Griffiths H, Tymms K, Nicholls D, Roberts L, Arnold M, Burnet S, et al. The SMILE study -- safety of methotrexate in combination with leflunomide in rheumatoid arthritis. J Rheumatol 2013; 40: 228-35. (In a cross sectional study of 2975 patients with rheumatoid arthritis in Australia, liver test abnormalities were reported in 12% on methotrexate alone, 16% on leflunomide alone and 19% on both). 23322457
Behrens F, Finkenwirth C, Pavelka K, Štolfa J, Šipek-Dolnicar A, Thaçi D, Burkhardt H. Leflunomide in psoriatic arthritis: results from a large European prospective observational study. Arthritis Care Res (Hoboken) 2013; 65: 464-70. (Among 514 European patients with psoriatic arthritis treated with leflunomide for 24 weeks, 2 had "serious" liver test abnormalities, but both resolved upon stopping). 23042698
Keen HI, Conaghan PG, Tett SE. Safety evaluation of leflunomide in rheumatoid arthritis. Expert Opin Drug Saf 2013; 12: 581-8. (Review of efficacy and safety of leflunomide in rheumatoid arthritis mentions the FDA boxed warning in 2010 in response to a review of 14 cases of acute liver failure, and the 113 adverse events reports of hepatobiliary disorders to the Australian and 512 to the WHO adverse event registries). 23668332
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none were attributed to leflunomide). 23419359
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, none of which were attributed to leflunomide) 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 5 [0.6%] were attributed to leflunomide all of which were jaundiced and one fatal). 25754159
Mo YQ, Liang AQ, Ma JD, Chen LF, Zheng DH, Schumacher HR, Dai L. Discontinuation of antiviral prophylaxis correlates with high prevalence of hepatitis B virus (HBV) reactivation in rheumatoid arthritis patients with HBV carrier state: a real-world clinical practice. BMC Musculoskelet Disord 2014; 15: 449. (Among 36 patients with rheumatoid arthritis and HBsAg in serum treated with disease modifying antirheumatic drugs, 13 had reactivation of hepatitis B [2 on lamivudine prophylaxis, 5 after discontinuation and 6 on no antivirals] of whom 6 had hepatitis, [3 on leflunomide], 3 were icteric and one developed cirrhosis) 25532827
Sultan SJ, Sameem F, Ashraf M. Drug reaction with eosinophilia and systemic symptoms: manifestations, treatment, and outcome in 17 patients. Int J Dermatol 2015; 54: 537-42. (Over a 4 year period, 17 patients were seen with DRESS syndrome at a single referral hospital in India, of which 6 were due to phenytoin 2 phenobarbital, 2 allopurinol and various others including leflunomide in 1; all had ALT elevations and 11 had hyperbilirubinemia and 1 died of liver failure) 24738653
Ming-Xu H, Chen M, Cai Y, Yan-Jia H. Clinical outcomes of low-dose leflunomide for rheumatoid arthritis complicated with hepatitis B virus carriage and safety observation. Pak J Med Sci 2015; 31: 320-4. (Among 115 patients with rheumatoid arthritis treated with leflunomide, 8 of 17 with HBsAg, but none of 36 with or 62 without antibody to HBV, developed rises in HBV DNA of whom 5 developed hepatitis [ALT 104 to 826 U/L] which was icteric in two, one of whom died of liver failure). 26101483
Stine JG, Lewis JH. Current and future directions in the treatment and prevention of drug-induced liver injury: a systematic review. Expert Rev Gastroenterol Hepatol 2016; 10: 517-36. (Comprehensive review of current means of treatment and prevention of drug-induced liver injury mentions that activated charcoal or cholestyramine may be beneficial in patients who develop liver injury while on leflunomide as these agents enhance clearance of the leflunomide which has a long half-life and enterohepatic circulation) 26633044
Xuan J, Ren Z, Qing T, Couch L, Shi L, Tolleson WH, Guo L. Mitochondrial dysfunction induced by leflunomide and its active metabolite. Toxicology. 2018;396-397:33-45. (Studies of the effects of leflunomide on hepatocytes in cell culture demonstrated time- and concentration-dependent toxicity that appeared to be mediated by effects on mitochondria). 29427785
Pliquett RU, Lübbert C, Schäfer C, Girndt M. Thrombotic microangiopathy and liver toxicity due to a combination therapy of leflunomide and methotrexate: a case report. J Med Case Rep. 2020;14:26.. (63 year old woman with rheumatoid arthritis on methotrexate for 8 years and leflunomide for 6 years developed thrombotic microangiopathy with liver test abnormalities [bilirubin 1.1 mg/dL, ALT 102 U/L, AST 78 U/L, INR 1.9] ultrasonography showing ascites and liver biopsy non-alcoholic fatty liver disease and cirrhosis; the abnormalities were attributed to the combination of methotrexate and leflunomide which were stopped). 32019572
Devarbhavi H, Ghabril M, Barnhart H, Patil M, Raj S, Gu J, Chalasani N, et al. Leflunomide-induced liver injury: differences in characteristics and outcomes in Indian and US registries. Liver Int. 2022;42:1323-1329.. (Comparison of 9 cases of leflunomide liver injury from an prospective database of drug-induced liver injury from India [0.8% of 1040 cases] and 8 cases from a prospective U.S. database [0.5% of 1400 cases] showed major differences in the clinical features, the Indian cases were mostly women all of whom had severe skin rash [6 with DRESS, 2 with SJS] after a median latency of 49 days while the U.S. cases were mostly men, none with severe skin rash, and with a median latency of 166 days). 35129282
Bessone F, Hernandez N, Medina-Caliz I, García-Cortés M, Schinoni MI, Mendizabal M, Chiodi D, et al. Drug-induced liver injury in Latin America: 10-year experience of the Latin American DILI (LATINDILI) Network. Clin Gastroenterol Hepatol. 2025;23:89-102.. (Among 483 cases of drug-induced liver injury enrolled in a prospective Latin American database between 2012 and 2022, one [0.2%] was attributed to leflunomide). 38992407
Chen VL, Rockey DC, Bjornsson ES, Barnhart H, Hoofnagle JH; Drug-Induced Liver Injury Network Investigators. Incidence of idiosyncratic drug-induced liver Injury caused by prescription drugs. Drug Saf. 2025;48:151-160. 39317916. (Analysis of 1284 cases of drug-induced liver injury enrolled in a U.S. prospective study between 2005 and 2019 included 9 cases [0.6%] attributed to leflunomide, but the estimated number of persons prescribed leflunomide were too few to accuracy assess the incidence but it was likely 1:1,000 to 1:5,000 exposed persons).
Yadav P, Rao GK, Rataboli PV, Gurav SS. Drug reaction with eosinophilia and systemic symptoms (DRESS) syndrome with multiple drugs (leflunomide and cefuroxime): a case report. Curr Drug Saf. 2025;20:388-393.. (Abstract only: 42 year old Indian woman developed fever, rash, facial edema, eosinophilia and liver injury after starting leflunomide for palmar fasciitis and recovered after drug withdrawal). 39301905
Aponte-Colon C, Cochran LA, Harris L, Mears EA, Frederick SW. Case report: fatal presumptive idiosyncratic hepatic necrosis secondary to standard-dose leflunomide administration in a dog. Front Vet Sci. 2025;12:1529324.. (8 year old male Greyhound with idiopathic polyarthritis developed lethargy 5 weeks after starting leflunomide [bilirubin 0.8 mg/dL, ALT 6613 U/L, Alk P 673 U/L] and died within a day of evaluation, autopsy demonstrating submassive hepatic necrosis). 40400669

## OTHER REFERENCE LINKS

1. Recent References on Leflunomide: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Leflunomide/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Leflunomide: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Leflunomide)